# Treosulfan

## OVERVIEW

### Introduction

Treosulfan is an alkylating agent used in combination with fludarabine as a conditioning regimen in preparation of hematopoietic stem cell transplantation in patients with acute myeloid leukemia or a myelodysplastic syndrome. Treosulfan is associated with a high rate of transient serum enzyme and bilirubin elevations during the peri-transplant period and can also cause sinusoidal obstruction syndrome which is usually reversible but can result in liver failure and death.

### Background

Treosulfan (tree" oh sul' fan) is a prodrug of a dihydroxybusulfan analogue and acts as a potent alkylating agent. Treosulfan alkylates and cross-links DNA, thereby interfering with DNA replication and RNA transcription and producing cytotoxicity in rapidly dividing cells, including hematopoietic progenitors. This myeloablative activity is the basis for its use as a conditioning agent in preparation for hematopoietic cell transplantation. Treosulfan was approved by the FDA in 2025 for use in combination with fludarabine in preparing for stem cell transplantation for acute myeloid leukemia and myelodysplastic syndromes in adults and children (1 year or older). Treosulfan is available as a lyophilized powder for injection in single-dose vials of 1 and 5 g under the brand name Grafapex. The recommended dose is 10 g/m^2^ daily for 3 days in combination with fludarabine 30 mg/m^2^ daily for 6 days, followed by stem cell infusion within at least 2 days after finishing conditioning. Common adverse reactions include myelosuppression, nausea, stomatitis, vomiting, diarrhea, fatigue, infections, febrile neutropenia and elevations in serum aminotransferase levels, bilirubin, and creatinine. Uncommon but potentially severe adverse reactions include sinusoidal obstruction syndrome and severe liver injury, prolonged myelosuppression, seizures, skin disorders, injection site reactions, secondary malignancies, early morbidity and mortality [at higher-than-recommended doses], and embryo-fetal toxicity.

### Hepatotoxicity

In a pre-registration-controlled trial comparing use of treosulfan vs busulfan combined with fludarabine, serum ALT elevations occurred in 50% vs 43% and were above 5 times the upper limit of normal (ULN) in 6% vs 4%. Bilirubin levels were also increased by therapy in more than 40% of patients and severe elevations (above 3 times ULN) in 6% vs 5%. Severe hepatotoxicity was diagnosed in 8% vs 3%. Most enzyme and bilirubin elevations were self-limited and reversible. Fatal regimen-related adverse reactions within 30 days of transplantation occurred in approximately 2% of patients, reflecting the overall toxicity of conditioning rather than isolated hepatic injury.

The clinically important form of hepatotoxicity associated with alkylating agents used in pre-transplant conditioning is hepatic sinusoidal obstruction syndrome (SOS), also known as veno-occlusive disease (VOD). Sinusoidal obstruction syndrome is a potentially fatal complication of myeloablative conditioning and is caused by damage to hepatic sinusoidal endothelial cells causing obstruction to the flow of blood that if severe enough leads to fibrotic obliteration of sinusoids and severe hepatic congestion. Symptoms of abdominal pain, weight gain, and fluid retention arise within 1 to 8 weeks after the myeloablative therapy accompanied by variable degrees of elevation of serum enzymes and bilirubin. Severe cases progress to hepatic failure. Treosulfan is claimed to have a lower incidence of severe sinusoid obstruction syndrome than busulfan, but in the large, controlled trial comparing treosulfan to busulfan combined with fludarabine, clinically apparent sinusoidal obstruction syndrome arose in less than 1% of both groups.

Likelihood score: C (probable cause of clinically apparent liver injury associated with myeloablation during conditioning for hematopoietic stem cell transplantation).

### Mechanism of Injury

The liver injury associated with treosulfan therapy is probably the result of direct cytotoxicity to sinusoidal lining cells resulting in variable degrees of sinusoidal obstruction syndrome.

### Outcome and Management

Use of treosulfan in conditioning regimens in preparation for hematopoietic stem cell transplantation is associated with frequent elevations in serum aminotransferase levels and bilirubin and hepatotoxicity in 5% to 10% of patients. The abnormalities are usually transient and resolve spontaneously without intervention. In severe instances sinusoidal obstruction syndrome can arise and require careful monitoring and medical support. There is no evidence for cross-sensitivity to liver injury of treosulfan with other alkylating agents used in conditioning regimens.

Drug Class: Antineoplastic Agents; Alkylating Agents

Other Drugs in the Subclass: Busulfan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Treosulfan – Grafapex®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Treosulfan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Treosulfan | 299-75-2 | C6H14O8S2 | SID: 51091591

## ANNOTATED BIBLIOGRAPHY

References updated: 14 September

Abbreviations used: ULN, upper limit of normal; iv, intravenously.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HH. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp 673-708. (Expert review of hepatotoxicity of antibiotics published in 1999, discusses veno-occlusive disease caused by busulfan used in preparation for bone marrow transplantation, but the book was published before the availability of treosulfan).
Wellstein A, Sausville EA. Alkyl sulfonates. Cytotoxics and antimetabolites. In, Brunton LL, Knollmann KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 14th ed. New York: McGraw-Hill, 2023, p. 1350. (Textbook of pharmacology and therapeutics discusses busulfan and its potential for causing sinusoidal obstruction syndrome but does not mention treosulfan).
Drugs@FDA. 2026. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/214759Orig1s000ChemR.pdf (FDA website with product label and FDA integrated review of efficacy and safety of treosulfan, based upon data submitted by the sponsor in support of its approval as a conditioning agent for hematopoietic stem cell transplantation, mentions that in the large pre-registration trial comparing treosulfan to busulfan, liver test abnormalities were frequent with both agents but usually self-limited in course, with ALT elevations above 5 times ULN arising in 6% vs 4% and sinusoidal obstruction syndrome in less than 1% in both groups).
Baronciani D, Rambaldi A, Iori AP, Di Bartolomeo P, Pilo F, Pettinau M, Depau C, et al. Treosulfan/fludarabine as an allogeneic hematopoietic stem cell transplant conditioning regimen for high-risk patients. Am J Hematol. 2008;83:717-20. (Among 46 patients with hematologic malignancies undergoing hematopoietic stem cell transplantation using a conditioning regimen that included treosulfan [12 or 14 g/m2], 13% developed liver toxicity but all were mild-to-moderate and self-limited in course, and none of the 6 transplant-related deaths were hepatic). 18626885
Ruutu T, Volin L, Beelen DW, Trenschel R, Finke J, Schnitzler M, Holowiecki J, et al. Reduced-toxicity conditioning wit2h treosulfan and fludarabine in allogeneic hematopoietic stem cell transplantation for myelodysplastic syndromes: final results of an international prospective phase II trial. Haematologica. 2011;96:1344-50. (Among 45 patients with myelodysplastic syndromes who underwent hematopoietic stem cell transplantation with treosulfan [14 g/m2] and fludarabine conditioning, 2-year overall survival was 71% and adverse events included 2 episodes of moderate, self-limited sinusoidal obstruction syndrome). 21659356
Remberger M, Törlen J, Serafi IE, Garming-Legert K, Björklund A, Ljungman P, Sundin M, et al. Toxicological effects of fludarabine and treosulfan conditioning before allogeneic stem-cell transplantation. Int J Hematol. 2017 Oct;106(4):471-475. (Among 118 patients undergoing stem cell transplantation with treosulfan based conditioning [14 g/m2/day for 3 days], ALT elevations above 5 times ULN arose in only 2 patients, and both resolved rapidly, while only 1 patient developed sinusoidal obstruction syndrome that was not severe and was self-limited in course). 28849374
Beelen DW, Trenschel R, Stelljes M, Groth C, Masszi T, Reményi P, Wagner-Drouet EM, et al. Treosulfan or busulfan plus fludarabine as conditioning treatment before allogeneic haemopoietic stem cell transplantation for older patients with acute myeloid leukaemia or myelodysplastic syndrome (MC-FludT.14/L): a randomised, non-inferiority, phase 3 trial. Lancet Haematol. 2020;7:e28-e39. (Among 476 patients with acute myeloid leukemia or myelodysplastic syndrome enrolled in a European open label trial comparing treosulfan to busulfan combined with fludarabine as conditioning regimens, 24-month overall survival was 71% vs 56%, serious adverse events rates were 8% vs 7%, and cases of sinusoid obstruction syndrome were none vs 1 [<1%]). 31606445
Sykora KW, Beier R, Schulz A, Cesaro S, Greil J, Gozdzik J, Sedlacek P, et al. Treosulfan vs busulfan conditioning for allogeneic BMT in children with nonmalignant disease: a randomized phase 2 trial (MC-FludT.16/NM). Bone Marrow Transplant. 2024;59:107-116. (Among 101 children undergoing bone marrow transplant for non-malignant disease randomized to treosulfan- vs busulfan-based myeloablative conditioning, all adverse event rates were 88% vs 96% and severe event rates were 35% vs 32%, while sinusoidal obstruction syndrome occurred in 2% vs 10% of patients and was severe in none vs 4%). 37925531
Zaidman I, Barsoum N, Even-Or E, Daher M, Aran AA, Stepensky P, Gefen A. Prognostic factors associated with increased mortality in pediatric veno-occlusive disease following hematopoietic cell transplantation. Clin Transplant. 2024;38:e70037 (Among 1243 children who underwent hematopoietic stem cell transplantation at 2 Israeli referral centers between 2001 and 2021, 101 developed sinusoidal obstructive syndrome, 50% of whom died, analysis of risk factors did not adjust for their frequency). 39601252
Lazzari L, Balaguer-Roselló A, Bruno A, et al. Impact of busulfan- versus treosulfan-based conditioning on the incidence of sinusoidal obstruction syndrome/veno-occlusive disease after allogeneic hematopoietic cell transplantation: a dual-center real-world study. Bone Marrow Transplant. 2025;61:118-120. (Among 927 patients who underwent hematopoietic stem cell transplantation at two European referral centers between 2017 and 2023 using either a treosulfan- vs busulfan-based conditioning regimen, sinusoidal obstruction syndrome occurred in 1.6% vs 6.9%, which were severe in 1.1% vs 3.8%, and cases after treosulfan had a longer median time to onset [56 vs 21 days]). 41254194
Avenoso D, Radici V, Leoni A, Skert C, Martino M, Mordini N, Saraceni F, et al. A phase II multicenter prospective study to evaluate the safety and efficacy of myeloablative-dose treosulfan plus fludarabine (FT14) conditioning regimen in allogeneic hematopoietic stem cell transplantation for AML patients aged 40-65 in first complete remission. Bone Marrow Transplant. 2026;61:1176-1181. (Among 82 patients with acute myeloid leukemia undergoing hematopoietic stem cell transplantation with treosulfan/fludarabine conditioning, the one-year overall survival rate was 90% and there were no cases of sinusoidal obstruction syndrome or serious hepatic adverse events). 42342968

## OTHER REFERENCE LINKS

1. Recent References on Treosulfan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Treosulfan%20+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Treosulfan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Treosulfan)